# Linaclotide

## OVERVIEW

### Introduction

Linaclotide is small peptide agonist of guanylate cyclase C receptors in the intestine and is used orally as treatment of chronic constipation and irritable bowel syndrome. Linaclotide has not been linked to serum enzyme elevations during treatment or to episodes of clinically apparent liver injury.

### Background

Linaclotide (lin ak’ loe tide) is 14 amino acid peptide that acts as an agonist of the guanylate cyclase C receptors in the intestine. Activation of this receptor by linaclotide increases cyclic guanosine monophosphate levels which lead to an increase in secretion of chloride and bicarbonate into the intestinal lumen, thus increasing fluid secretion and promoting intestinal transit. Linaclotide acts locally on the luminal side of enterocytes in the upper intestine and is minimally absorbed. Several clinical trials have shown that linaclotide increases the number of spontaneous bowel movements, improves stool consistency and can alleviate symptoms of chronic constipation including the constipation of irritable bowel syndrome. Linaclotide was approved for use in the United States in 2012 for irritable bowel syndrome with constipation as well as idiopathic chronic constipation. Linaclotide is available in capsules of 72, 145 and 290 mcg under the brand name Linzess. The recommended dose for chronic idiopathic constipation is 72 or 145 mcg once daily and for irritable bowel syndrome with constipation is 290 mcg once daily. It is contraindicated in children below the age of 6 years and is not recommended for use in children below the age of 18 years. Side effects include diarrhea (~20%), abdominal pain, bloating, flatulence and headache. Rare but potentially severe adverse events include severe dehydration particularly in children.

### Hepatotoxicity

In clinical trials, linaclotide therapy was not associated with significant changes in serum enzyme levels or episodes of clinically apparent liver injury. Minor transient ALT elevations arose in <1% of persons receiving long-term linaclotide therapy for constipation. Since its approval and marketing, there have been no reports of symptomatic serum aminotransferase elevations or clinically apparent liver injury with jaundice attributable to linaclotide. Thus, liver injury from linaclotide must be rare if it occurs at all.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

Linaclotide is largely active on the epithelial cells in the intestinal tract and has minimal absorption. The lack of systemic absorption and the low doses used (in microgram amounts) may account for its lack of liver injury.

Drug Class: Gastrointestinal Agents, Drugs for Constipation, Irritable Bowel Syndrome Agents

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Linaclotide – Generic, Linzess®

DRUG CLASS

Gastrointestinal Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Linaclotide)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Linaclotide | 851199-59-2 | C59-H79-N15-O23-S6 | Linaclotide Chemical Structure

## ANNOTATED BIBLIOGRAPHY

References updated: 13 May 2019

Zimmerman HJ. Laxatives. In, Zimmerman, HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999: pp. 721-3. (Expert review of hepatotoxicity of laxatives published in 1999 with discussion of oxyphenisatin and other agents, but not linaclotide).
Sharkey KA, McNaughton WK. Treatment of disorders of bowel motility and water flux: anti-emetics; agents used in biliary and pancreatic disease. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 921-44. (Textbook of pharmacology and therapeutics).
https://www.accessdata.fda.gov/drugsatfda_docs/nda/2012/202811Orig1s000MedR.pdf ( FDA Drug Approvals website that has product labels [package inserts], letters of approval and full FDA scientific review of the new drug application for safety and efficacy; mentions that ALT elevations above 3 times ULN occurred in 0.5% of 3173 patients in long-term safety trials of linaclotide, but that no cases of ALT elevations with jaundice were reported).
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J; Drug Induced Liver Injury Network(DILIN). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology 2008; 135: 1924-34. (Among 300 cases of drug induced liver disease in the US collected between 2004 and 2008, none were attributed to agents used for constipation or irritable bowel syndrome [IBS]). 19132805
Reuben A, Koch DG, Lee WM; Acute Liver Failure Study Group. Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology 2010; 52: 2065-76. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury, but none were attributed to gastrointestinal agents, laxatives or drugs for IBS). 20949552
Shah E, Kim S, Chong K, Lembo A, Pimentel M. Evaluation of harm in the pharmacotherapy of irritable bowel syndrome. Am J Med 2012; 125: 381-93. (Systematic review of adverse side effects of drugs used to treat irritable bowel syndrome including lubiprostone, but not linaclotide). 22444104
Lembo AJ, Schneier HA, Shiff SJ, Kurtz CB, MacDougall JE, Jia XD, Shao JZ, et al. Two randomized trials of linaclotide for chronic constipation. N Engl J Med 2011; 365: 527-36. (Among 1276 patients with chronic constipation treated with linaclotide or placebo for 12 weeks, diarrhea was the most common side effect [14-16% vs 4.7% in controls] and "there were no clinically significant differences in...blood chemistry values" between the two groups). 21830967
Rao S, Lembo AJ, Shiff SJ, Lavins BJ, Currie MG, Jia XD, Shi K, et al. A 12-week, randomized, controlled trial with a 4-week randomized withdrawal period to evaluate the efficacy and safety of linaclotide in irritable bowel syndrome with constipation. Am J Gastroenterol 2012; 107: 1714-24. (Among 800 patients with constipation predominant IBS treated with linaclotide or placebo for 12 weeks, the most common side effect was diarrhea [20% vs 3.5% with placebo] and there were "no clinically significant differences between the linaclotide and placebo groups in the incidence of abnormal laboratory parameters"). 22986440
Chey WD, Lembo AJ, Lavins BJ, Shiff SJ, Kurtz CB, Currie MG, MacDougall JE, et al. Linaclotide for irritable bowel syndrome with constipation: a 26-week, randomized, double-blind, placebo-controlled trial to evaluate efficacy and safety. Am J Gastroenterol 2012; 107: 1702-12. (Among 804 patients with IBS and constipation treated for 12 weeks, pain, bloating and bowel symptoms were improved with linaclotide compared to placebo therapy and side effects were similar except for diarrhea with linaclotide, and "there were no clinically meaningful differences...in the incidence of abnormal laboratory parameters"). 22986437
Linaclotide (Linzess) for constipation. Med Lett Drugs Ther 2012; 54 (1403): 91-2. (Concise summary of the mechanism of action, efficacy and safety of linaclotide for constipation shortly after its approval in the United States; no mention of ALT elevations or hepatotoxicity). 23183319
Quigley EM, Tack J, Chey WD, Rao SS, Fortea J, Falques M, Diaz C, et al. Randomised clinical trials: linaclotide phase 3 studies in IBS-C - a prespecified further analysis based on European Medicines Agency-specified endpoints. Aliment Pharmacol Ther 2013; 37: 49-61. (Reanalysis of controlled trials of linaclotide for constipation predominant IBS [Rao 2012, Chey 2012] using different endpoints; no further discussion of side effects). 23116208
Berntgen M, Enzmann H, Schabel E, Prieto Yerro C, Gómez-Outes A, Salmonson T, Musaus J. Linaclotide for treatment of irritable bowel syndrome--the view of European regulators. Dig Liver Dis 2013; 45: 724-6. (Review of the efficacy and safety of linaclotide in IBS which led to the approval of its use by the European Medicines Agency). 23701993
Lacy BE, Schey R, Shiff SJ, Lavins BJ, Fox SM, Jia XD, Blakesley RE, et al. Linaclotide in chronic idiopathic constipation patients with moderate to severe abdominal bloating: a randomized, controlled trial. PLoS One 2015; 10: e0134349. (Among 483 patients with chronic idiopathic constipation and abdominal bloating treated with linaclotide [145 or 290 mcg] or placebo once daily for 12 weeks, abdominal symptoms improved more frequently while adverse event rates were slightly higher with linaclotide, diarrhea occurring in 6% and 17% vs 2.3% with placebo; no mention of ALT elevations or hepatotoxicity). 26222318
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, one case was attributed to metoclopramide, but none to other prokinetic agents or drugs for chronic idiopathic constipation). 25754159
Black CJ, Ford AC. Chronic idiopathic constipation in adults: epidemiology, pathophysiology, diagnosis and clinical management. Med J Aust 2018; 209: 86-91. (Review of the role of guanylate cyclase C in gastrointestinal physiology and the biologic basis for the use of guanylate cyclase receptor agonists as therapy of gastrointestinal disorders). 29996755
Waldman SA, Camilleri M. Guanylate cyclase-C as a therapeutic target in gastrointestinal disorders. Gut 2018; 67: 1543-52. (Review of the definition, diagnosis, epidemiology, pathophysiology, clinical features and management and drug therapy of chronic idiopathic constipation). 29563144
Schoenfeld P, Lacy BE, Chey WD, Lembo AJ, Kurtz CB, Reasner DS, Bochenek W, et al. Low-dose linaclotide (72 μg) for chronic idiopathic constipation: a 12-week, randomized, double-blind, placebo-controlled trial. Am J Gastroenterol 2018; 113: 105-14. (Among 1223 patients with chronic idiopathic constipation treated with linaclotide [72 or 145 mcg] or placebo once daily for 12 weeks, overall response rates were higher with linaclotide [13% vs 4.7%] and the major side effect was diarrhea [19% and 22% vs 7%] and there were no hepatic serious adverse events and no mention of ALT elevations). 29091082
Nee JW, Johnston JM, Shea EP, Walls CE, Tripp K, Shiff S, Fox SM, et al. Safety and tolerability of linaclotide for the treatment of chronic idiopathic constipation and irritable bowel syndrome with constipation: pooled phase 3 analysis. Expert Rev Gastroenterol Hepatol 2019; 13: 397-406. (Among 3853 adults evaluated in a pooled safety analysis of placebo-controlled trials of linaclotide therapy of chronic idiopathic constipation, adverse events occurring more frequently with linaclotide were diarrhea [17-20%] and abdominal pain [4-7%], and "laboratory values showed no consequential changes from baseline"). 30791771
Fukudo S, Miwa H, Nakajima A, Kinoshita Y, Kosako M, Hayashi K, Akiho H, et al. High-dose linaclotide is effective and safe in patients with chronic constipation: A phase III randomized, double-blind, placebo-controlled study with a long-term open-label extension study in Japan. Neurogastroenterol Motil 2019; 31: e13487. (Among 186 Japanese adults with chronic constipation treated with linaclotide [500 mcg daily] in a 4 week placebo controlled trial followed by 52 weeks of open-label therapy, the most frequent adverse event was diarrhea [13% vs 1%], but there were no hepatic serious adverse events and "no clinically significant differences in hematologic or blood chemical results"). 30353619

## OTHER REFERENCE LINKS

1. Recent References on Linaclotide: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Linaclotide+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Linaclotide: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Linaclotide)